# Vorinostat

## OVERVIEW

### Introduction

Vorinostat is an oral histone deacetylase inhibitor and antineoplastic agent that is approved for use in refractory or relapsed cutaneous T cell lymphoma. Vorinostat is associated with modest rate of minor serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury.

### Background

Vorinostat (vor in' oh stat) is an oral small molecule inhibitor of histone deacetylase which acts by preventing removal of acetyl groups from histones. The accumulation of acetyl groups on histones causes cell cycle arrest and apoptotic cell death. Malignant cells and particularly malignant T cells are particularly sensitive to the effects of inhibition of histone deacetylases. In open label studies in patients with refractory cutaneous T cell lymphoma (CTCL), monotherapy with vorinostat yielded an overall response rate of 30%, and some responders had long term remissions and were able to undergo hematopoietic cell transplantation. Vorinostat has also been evaluated in B cell lymphomas and in several forms of solid tumors, but with only modest results. Vorinostat was approved for use in the United States in 2006 as monotherapy for refractory or relapsing cutaneous T cell lymphoma, the first histone deacetylase inhibitor approved as an anticancer agent. Vorinostat is available in capsules of 100 mg under the commercial name Zolinza. The recommended dose is 400 mg daily by mouth, continuing therapy until there is disease progression or unacceptable toxicity. Side effects are common, but usually mild-to-moderate in severity, and include nausea, fatigue, fever, anemia, neutropenia, thrombocytopenia, diarrhea, constipation, rash, edema, cough and pruritus. Side effects lead to early discontinuation in up to 8% of patients. Severe adverse events can include marked neutropenia, thrombocytopenia, serious infections, sepsis, tumor lysis syndrome and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials of vorinostat in patients with CTCL, the rates of serum enzyme elevations during therapy were rarely mentioned and only occasional episodes of mild elevations were recorded. Minor elevations in serum ALT levels occurred in 15% to 45% of patients, but values above 5 times ULN were rare and there were no reports of hepatitis, jaundice or clinically apparent liver injury among the treated subjects. Vorinostat has had limited clinical use, but there have been no published reports of its association with significant liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why vorinostat might cause serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of histone deacetylase or other enzyme activities. Vorinostat is metabolized in the liver by glucuronidation and is not a substrate, inhibitor or inducer of cytochrome P450 enzymes.

### Outcome and Management

Serum enzyme elevations can occur during vorinostat therapy, but they are usually transient and mild-to-moderate in severity, rarely requiring dose modification. There is no known cross sensitivity to hepatic injury among the different histone deacetylase inhibitors.

Drug Class: Antineoplastic Agents, Histone Deacetylase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vorinostat – Zolinza®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Vorinostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Vorinostat | 149647-78-9 | C14-H20-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September 2020

Abbreviation: CTCL, cutaneous T-cell lymphoma.
Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of histone deacetylase inhibitors).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss vorinostat).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1230. (Textbook of pharmacology and therapeutics).
Kelly WK, O'Connor OA, Krug LM, Chiao JH, Heaney M, Curley T, MacGregore-Cortelli B, et al. (2005). Phase I study of an oral histone deacetylase inhibitor, suberoylanilide hydroxamic acid, in patients with advanced cancer. J Clin Oncol. (Among 73 patients with different forms of advanced cancer treated with several regimens of vorinostat, the maximum tolerated dose was 400 mg daily and toxicities included fatigue, anorexia, nausea, diarrhea, bone marrow suppression, hyperglycemia, creatinine elevations and proteinuria; no mention of ALT elevations).
Olsen EA, Kim YH, Kuzel TM, Pacheco TR, Foss FM, Parker S, Frankel SR, et al. (2007). Phase IIb multicenter trial of vorinostat in patients with persistent, progressive, or treatment refractory cutaneous T-cell lymphoma. J Clin Oncol. (Among 74 patients with refractory or relapsed CTCL treated with vorinostat, the overall response rate was 30% and adverse events included diarrhea [49%], fatigue [46%], nausea [43%] and anorexia [26%]; no mention of ALT elevations or hepatotoxicity).
Duvic M, Talpur R, Ni X, Zhang C, Hazarika P, Kelly C, Chiao JH, et al. (2007). Phase 2 trial of oral vorinostat (suberoylanilide hydroxamic acid, SAHA) for refractory cutaneous T-cell lymphoma (CTCL). Blood. (Among 33 patients with refractory or relapsed CTCL treated with vorinostat, the overall response rate was 24% and side effects were common, serious adverse events being dehydration, thrombocytopenia, vomiting, anemia, neutropenia and infections; no mention of ALT elevations or hepatotoxicity).
(2007). Vorinostat (Zolinza) for cutaneous T-Cell lymphoma. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of vorinostat shortly after its approval for use in the US; mentions serious adverse events of pulmonary embolism, squamous cell carcinoma of skin and fetal abnormalities).
Crump M, Coiffier B, Jacobsen ED, Sun L, Ricker JL, Xie H, Frankel SR, et al. (2008). Phase II trial of oral vorinostat (suberoylanilide hydroxamic acid) in relapsed diffuse large-B-cell lymphoma. Ann Oncol. (Among 18 patients with relapsed B cell lymphoma treated with vorinostat, the overall response rate was 5% [1 patient] and serious adverse events occurred in 7 patients [39%], mostly hematologic and gastrointestinal events; no mention of ALT elevations or hepatotoxicity).
Duvic M, Olsen EA, Breneman D, Pacheco TR, Parker S, Vonderheid EC, Abuav R, et al. (2009). Evaluation of the long-term tolerability and clinical benefit of vorinostat in patients with advanced cutaneous T-cell lymphoma. Clin Lymphoma Myeloma. (Six of the 74 patients with CTCL enrolled in a trial of vorinostat were treated for 2 years, all with only moderate toxicities).
Traynor AM, Dubey S, Eickhoff JC, Kolesar JM, Schell K, Huie MS, Groteluschen DL, et al. (2009). Vorinostat (NSC# 701852) in patients with relapsed non-small cell lung cancer: a Wisconsin Oncology Network phase II study. J Thorac Oncol. (Among 18 patients with relapsed NSCLC treated with vorinostat, there were no partial or complete response and side effects were common; no mention of ALT elevations or hepatotoxicity).
Kavanaugh SM, White LA, Kolesar JM. (2010). Vorinostat: A novel therapy for the treatment of cutaneous T-cell lymphoma. Am J Health Syst Pharm. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of vorinostat therapy of cutaneous T cell lymphoma mentions an overall response rate of 30% and frequency of side effects including fatigue in 52%, nausea in 41%, but no mention of ALT elevations or hepatotoxicity).
Kirschbaum M, Frankel P, Popplewell L, Zain J, Delioukina M, Pullarkat V, Matsuoka D, et al. (2011). Phase II study of vorinostat for treatment of relapsed or refractory indolent non-Hodgkin's lymphoma and mantle cell lymphoma. J Clin Oncol. (Among 35 patients with non-Hodgkin lymphoma treated with vorinostat for an average of 6 months, overall response rates were 29% in follicular lymphoma, but 0% with mantle cell lymphoma; ALT or AST elevations occurred in 2 patients [3%], but both were transient and less than 3 times ULN).
Kirschbaum MH, Goldman BH, Zain JM, Cook JR, Rimsza LM, Forman SJ, Fisher RI. (2012). A phase 2 study of vorinostat for treatment of relapsed or refractory Hodgkin lymphoma: Southwest Oncology Group Study S0517. Leuk Lymphoma. (Among 25 patients with refractory or relapsed Hodgkin lymphoma treated with vorinostat for an average of 3.8 months, the overall response rate was 8%; no mention of ALT elevations or hepatotoxicity).
Ogura M, Ando K, Suzuki T, Ishizawa K, Oh SY, Itoh K, Yamamoto K, et al. (2014). A multicentre phase II study of vorinostat in patients with relapsed or refractory indolent B-cell non-Hodgkin lymphoma and mantle cell lymphoma. Br J Haematol. (Among 39 patients with follicular lymphoma treated with vorinostat, the overall response rate was 39%; adverse events were common, but no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, none of which were attributed to vorinostat).
Krug LM, Kindler HL, Calvert H, Manegold C, Tsao AS, Fennell D, Öhman R, et al. (2015). Vorinostat in patients with advanced malignant pleural mesothelioma who have progressed on previous chemotherapy (VANTAGE-014): a phase 3, double-blind, randomised, placebo-controlled trial. Lancet Oncol. (Among 661 patients with advanced mesothelioma treated with vorinostat or placebo, median overall survival was not improved by vorinostat, which had higher rates of adverse events including nausea, vomiting, diarrhea, anorexia, weight loss, and fever while ALT elevations were uncommon [1% vs none]).
Duvic M, Dimopoulos M. (2016). The safety profile of vorinostat (suberoylanilide hydroxamic acid) in hematologic malignancies: A review of clinical studies. Cancer Treat Rev. (Review of the adverse event rates in various trials of vorinostat and comparison to other histone deacetylase inhibitors reported a high rate of adverse events that were serious and drug related in 15% of patients and led to drug discontinuation in 8%; the most common side effects were diarrhea, nausea, fatigue and thrombocytopenia; only rare and occasional ALT elevation noted and no mention of hepatotoxicity or clinically apparent liver injury).
Schmitt T, Mayer-Steinacker R, Mayer F, Grünwald V, Schütte J, Hartmann JT, Kasper B, et al. (2016). Vorinostat in refractory soft tissue sarcomas - Results of a multi-centre phase II trial of the German Soft Tissue Sarcoma and Bone Tumour Working Group (AIO). Eur J Cancer. (Open label study of vorinostat in 40 patients with advanced soft tissue sarcoma found a low response rate while adverse events were largely hematologic [15%], gastrointestinal [13%], fatigue {10%] and musculoskeletal pain [10%]; no mention of ALT elevations or hepatotoxicity).
Bringhen S, De Wit E, Dimopoulos MA. (2017). New agents in multiple myeloma: an examination of safety profiles. Clin Lymphoma Myeloma Leuk. (Review of the safety profiles and adverse events of newer drugs for multiple myeloma including the histone deacetylase inhibitors – romidepsin, vorinostat and panobinostat, mentions that ALT elevations above 5 times ULN occur in 8% of patients treated with romidepsin, but no mention of ALT elevations or hepatotoxicity with vorinostat or panobinostat).
Moskowitz AJ, Horwitz SM. (2017). Targeting histone deacetylases in T-cell lymphoma. Leuk Lymphoma. (Extensive review of the mechanism of action, classification, clinical efficacy and safety of histone deacetylase inhibitors in T-cell lymphomas, mentions that vorinostat is an oral hydroxamate that is approved for use in refractory or relapsed cutaneous T cell lymphoma, more common adverse effects of which are fatigue, diarrhea, nausea, dysgeusia, thrombocytopenia, anorexia, weight loss and muscle spasms; no mention of ALT elevations or hepatotoxicity).
Kim YH, Bagot M, Pinter-Brown L, Rook AH, Porcu P, Horwitz SM, Whittaker S, et al. (2018). MAVORIC Investigators. Mogamulizumab versus vorinostat in previously treated cutaneous T-cell lymphoma (MAVORIC): an international, open-label, randomised, controlled phase 3 trial. Lancet Oncol. (Among 372 adults with refractory or relapsed mycosis fungoides or Sezary syndrome treated with either vorinostat or mogamulizumab [monoclonal anti-C-C chemokine receptor 4], median progression free survival was less with vorinostat [3.1 vs 7.7 months], while adverse event rates were similar including AST elevations [6.5% vs 4.35]; no mention of hepatotoxicity or clinically apparent liver injury).
Shah RR. (2019). Safety and tolerability of histone deacetylase (HDAC) inhibitors in oncology. Drug Saf. (Review of the safety of histone deacetylase inhibitors approved for use in the US mentions that elevations in serum aminotransferase levels have been reported during therapy with romidepsin, panobinostat and belinostat but not with vorinostat, and there have been no reports of clinically apparent hepatotoxicity, except for a single case of hepatic failure arising during a clinical trial of belinostat).

## OTHER REFERENCE LINKS

1 Recent References on Vorinostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vorinostat/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Vorinostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vorinostat)